# Cetuximab

## OVERVIEW

### Introduction

Cetuximab is a chimeric mouse-human monoclonal antibody to the human epidermal growth factor (EGF) receptor which is used in the treatment of metastatic colon and head and neck cancers. Cetuximab has been linked to mild and transient serum enzyme elevations during therapy, but has not been implicated in cases of clinically apparent acute liver injury.

### Background

Cetuximab (se tux’ i mab) is a chimeric mouse-human monoclonal IgG1 kappa antibody to the human epidermal growth factor (EGF) receptor which is present on many normal cell types and is overexpressed in several forms of cancer. Cetuximab has been shown to prolong survival in patients with EGF receptor expressing and wild type KRAS expressing colorectal cancer. Cetuximab has also been shown to be effective in patients with squamous cell carcinoma of the head and neck. Cetuximab was approved for use the United States in 2004 and current indications include metastatic colorectal and head and neck cancer usually in combination with other antineoplastic agents or radiation therapy. Cetuximab is available in liquid solution of 100 and 200 mg in single dose vials (2 mg/mL) under the brand name Erbitux. The recommended regimen is 400 mg/m^2^ by intravenous infusion initially and 250 mg/m^2^ weekly thereafter. Common side effects include infusion reactions (premedication with antihistamines is recommended), chills, fever, acne, skin rash, fatigue, headache and diarrhea. Less common but potentially serious side effects include severe cutaneous reactions, infections, acute renal failure, pulmonary embolus and cardiopulmonary arrest.

### Hepatotoxicity

Publications on the large scale trials of cetuximab, rates of ALT elevations and clinically apparent liver injury were usually not mentioned. In a study of squamous cell carcinoma of the head and neck, some degree of ALT elevation was reported in 45% of persons receiving cetuximab and radiation therapy versus 22% of those receiving radiation alone, but elevations above 5 times the ULN were rare (2% vs 1%). During the initial clinical trials and subsequent to its approval and more wide scale use, there have been no published reports of cetuximab hepatotoxicity.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the serum enzyme elevations during cetuximab therapy is not known. However, the human EGF receptor is present on many cells and some of the adverse events, including mild liver injury, may be due to a direct effect of the monoclonal antibody on cells that express EGF receptors.

### Outcome and Management

The serum aminotransferase elevations that occur on cetuximab therapy are generally transient, mild and asymptomatic and do not require dose modification or delay in therapy. Elevations above 5 times the upper limit of normal should lead to more careful monitoring and discontinuation or delay in therapy until levels return to normal or near normal levels. There is no information on cross reactivity of liver injury among the different monoclonal antibodies. Panitumumab is another monoclonal antibody to EGFR that is approved for use in the United States for metastatic colorectal cancer. Panitumumab is a human monoclonal IgG2 antibody and has a similar profile of side effects to cetuximab, except for a lower rate of infusion reactions.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cetuximab – Erbitux®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Cetuximab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Cetuximab | 205923-56-4 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 03 October 2017

Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Two new drugs for colon cancer. Med Lett Drugs Ther 2004; 46 (1184):46-8. (Concise review of mechanism of action, clinical efficacy, and cost of bevacizumab and cetuximab, two antineoplastic monoclonal antibodies, shortly after their approval in the US; adverse effects of cetuximab include acne [which is common and can be severe], infusion reactions, asthenia, diarrhea, nausea, vomiting and abdominal pain and rarely interstitial pneumonitis; no mention of hepatotoxicity). 15184808
Cunningham D, Humblet Y, Siena S, Khayat D, Bleiberg H, Santoro A, Bets D, et al. Cetuximab monotherapy and cetuximab plus irinotecan in irinotecan-refractory metastatic colorectal cancer. N Engl J Med 2004; 351 337-45. (Among 329 patients with metastatic colorectal cancer treated with cetuximab and irinotecan or cetuximab alone, side effects included acne like rash [89%], but no mention of ALT elevations or hepatotoxicity). 15269313
Saltz LB, Meropol NJ, Loehrer PJ Sr, Needle MN, Kopit J, Mayer RJ. Phase II trial of cetuximab in patients with refractory colorectal cancer that expresses the epidermal growth factor receptor. J Clin Oncol. 2004; 22 (7): 1201-8. (Among 57 patients with EGFR expressing, metastatic refractory colorectal cancer treated with cetuximab, common adverse events included acne-like skin rash [86%], fatigue [56%] and allergic reactions; no mention of ALT elevations or hepatotoxicity). 14993230
Vermorken JB, Trigo J, Hitt R, Koralewski P, Diaz-Rubio E, Rolland F, Knecht R, et al. Open-label, uncontrolled, multicenter phase II study to evaluate the efficacy and toxicity of cetuximab as a single agent in patients with recurrent and/or metastatic squamous cell carcinoma of the head and neck who failed to respond to platinum-based therapy. J Clin Oncol 2007; 25: 2171-7. (Among 103 patients with metastatic or recurrent head and neck cancer treated with cetuximab, adverse events included rash, acne and fatigue, and there were 6 infusion related reactions, including one death; no mention of ALT elevations or hepatotoxicity). 17538161
Pinto C, Di Fabio F, Siena S, Cascinu S, Rojas Llimpe FL, Ceccarelli C, Mutri V, et al. Phase II study of cetuximab in combination with FOLFIRI in patients with untreated advanced gastric or gastroesophageal junction adenocarcinoma (FOLCETUX study). Ann Oncol 2007; 18: 510-7. (Among 38 patients with advanced gastric carcinoma who received FOLFIRI chemotherapy and intravenous cetuximab [weekly], adverse events include in acne in 31 [82%], hypomagnesemia in 13 [34%], and elevated ALT levels in 10 [26%] which were above 5 times ULN in 2 [5%]). 17164226
Lenz HJ, Van Cutsem E, Khambata-Ford S, Mayer RJ, Gold P, Stella P, Mirtsching B, et al. Multicenter phase II and translational study of cetuximab in metastatic colorectal carcinoma refractory to irinotecan, oxaliplatin, and fluoropyrimidines. J Clin Oncol 2006; 24: 4914-21. (Among 346 patients with metastatic, advanced colorectal cancer treated with cetuximab, adverse events included rash [90%], fatigue [20%], headache [20%], diarrhea [13%], nausea [12%] and hypersensitivity reactions [7%]; no mention of ALT elevations or hepatotoxicity). 17050875
Cleary JM, Tanabe KT, Lauwers GY, Zhu AX. Hepatic toxicities associated with the use of preoperative systemic therapy in patients with metastatic colorectal adenocarcinoma to the liver. Oncologist 2009; 14: 1095-105. (Review of toxicities of preoperative chemotherapy for metastatic colorectal cancer including steatohepatitis after irinotecan [4-20%] and sinusoidal dilatation after oxaliplatin [10-78%]; the effects of cetuximab on the liver are not well described, but there is little to suggest that it interferes with hepatic regeneration). 19880627
Nie F, Shen J, Tong JL, Xu XT, Zhu MM, Ran ZH. Meta-analysis: the efficacy and safety of monoclonal antibody targeted to epidermal growth factor receptor in the treatment of patients with metastatic colorectal cancer. J Dig Dis 2009; 10: 247-57 (Systematic review of efficacy and safety of monoclonal antibodies to EGFR in metastatic colorectal cancer; summarized 7 randomized trials with 4186 patients using cetuximab or panitumumab, reported similar rates of response and adverse events with the two agents; no mention of ALT elevations or hepatotoxicity). 19906103
Ettinger DS. Emerging profile of cetuximab in non-small cell lung cancer. Lung Cancer 2010; 68: 332-7. (Review of the efficacy of cetuximab in non-small cell cancer does not mention ALT elevations or hepatotoxicity). 19783064
Baumgaertner I, Ratziu V, Vaillant JC, Hannoun L, Poynard T, André. [Hepatotoxicity of metastatic colorectal cancer chemotherapy: systematic review]. Bull Cancer 2010; 97 (5): 559-69. (Review of the hepatotoxicity of agents used for metastatic colorectal cancer mentions that the anti-EGFR monoclonal antibodies have not been reported to cause liver injury). 20167564
Pessaux P, Panaro F, Casnedi S, Zeca I, Marzano E, Bachellier P, Jaeck D, Chenard MP. Targeted molecular therapies(cetuximab and bevacizumab) do not induce additional hepatotoxicity: preliminary results of a case-control study. Eur J Surg Oncol 2010; 36: 575-82. (Among 36 patients with colorectal cancer undergoing hepatic resection after chemotherapy, steatohepatitis was less frequent in 21 patients who received bevacizumab than matched controls [5% vs 33%], and sinusoidal obstruction syndrome was less frequent in 15 patients given cetuximab than controls [0% vs 33%]). 20452168
Pessaux P, Marzano E, Casnedi S, Bachellier P, Jaeck D, Chenard MP. Histological and immediate postoperative outcome after preoperative cetuximab: case-matched control study. World J Surg 2010; 34: 2765-72. (Among 26 patients with metastatic colorectal cancer undergoing preoperative chemotherapy who also received cetuximab, serum enzyme and bilirubin elevations were similar to 26 matched control patients and liver histology showed no differences in rates of steatohepatitis, sinusoidal obstruction syndrome or fibrosis). 20652697
Tveit KM, Guren T, Glimelius B, Pfeiffer P, Sorbye H, Pyrhonen S, Sigurdsson F, et al. Phase III trial of cetuximab with continuous or intermittent fluorouracil, leucovorin, and oxaliplatin (Nordic FLOX) versus FLOX alone in first-line treatment of metastatic colorectal cancer: the NORDIC-VII study. J Clin Oncol 2012; 30: 1755-62. (Among 571 patients with metastatic colorectal cancer treated with continuous or intermittent fluorouracil, leucovorin and oxaliplatin, progression free and overall survival were similar with or without added cetuximab, and adverse events were similar except for rash [22% and 29% vs 1%]; no mention of ALT elevations or hepatotoxicity). 22473155
Stremitzer S, Sebio A, Stintzing S, Lenz HJ. Panitumumab safety for treating colorectal cancer. Expert Opin Drug Saf 2014; 13: 843-51. (Review of mechanism of action and safety of panitumumab therapy of metastatic colorectal cancer discusses skin toxicity, hypomagnesemia, diarrhea and infusion reactions [which are less with panitumumab than cetuximab], but not hepatotoxicity or ALT elevations). 24766434
Pujol JL, Pirker R, Lynch TJ, Butts CA, Rosell R, Shepherd FA, Vansteenkiste J, et al. Meta-analysis of individual patient data from randomized trials of chemotherapy plus cetuximab as first-line treatment for advanced non-small cell lung cancer. Lung Cancer 2014; 83: 211-8. (In a metaanalysis of results on 1970 patients from 4 controlled trials of cetuximab, severe adverse events that were more common with cetuximab were acne like rash, leucopenia, febrile neutropenia, septic events, fatigue, diarrhea and infusion reactions; no mention of ALT elevations or hepatotoxicity). 24332319
Satoh T, Gemma A, Kudoh S, Sakai F, Yamaguchi K, Watanabe T, Ishiguro M, et al. Incidence and clinical features of drug-induced lung injury in patients with advanced colorectal cancer receiving cetuximab: results of a prospective multicenter registry. Jpn J Clin Oncol 2014; 44: 1032-9. (Among 2006 Japanese adults with colorectal cancer treated with cetuximab, 24 developed drug induced lung injury, but no mention of concurrent liver injury or ALT elevations). 25210144
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 were attributed to antineoplastic agents, but none to cetuximab). 25754159
Enzinger PC, Burtness BA, Niedzwiecki D, Ye X, Douglas K, Ilson DH, Villaflor VM, et al. CALGB 80403 (Alliance)/E1206: a randomized phase II study of three chemotherapy regimens plus cetuximab in metastatic esophageal and gastroesophageal junction cancers. J Clin Oncol 2016; 34: 2736-42. (Among 245 patients with metastatic esophageal cancers treated with cetuximab and one of 3 chemotherapeutic regimens, adverse events were common, but there were no hepatic related deaths). 27382098
Bossi P, Miceli R, Locati LD, Ferrari D, Vecchio S, Moretti G, Denaro N, et al. A randomized, phase 2 study of cetuximab plus cisplatin with or without paclitaxel for the first-line treatment of patients with recurrent and/or metastatic squamous cell carcinoma of the head and neck. Ann Oncol 2017; 28 (11): 2820-6. (Among 201 patients with recurrent or metastatic head and neck cancer treated with cetuximab and cisplatin with or without paclitaxel, the medial progression-free and overall survival were similar, and ALT or AST elevations above 5 times ULN occurred in 4.4% vs 5.0%). 28950305

## OTHER REFERENCE LINKS

1. Recent References on Cetuximab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cetuximab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Cetuximab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Cetuximab)